# Eteplirsen

## OVERVIEW

### Introduction

Eteplirsen is a synthetic antisense oligonucleotide designed to cause skipping of abnormal exons during synthesis of the dystrophin gene and that is used to treat Duchenne muscular dystrophy. Clinical experience with eteplirsen has been limited, but it has not been linked to serum enzyme elevations or to instances of acute liver injury with symptoms and jaundice.

### Background

Eteplirsen (e” tep lir’ sen) is a synthetic antisense oligonucleotide designed to cause exon 51 skipping in the processing of mRNA for the dystrophin gene, which encodes an essential protein for muscle integrity. Patients with Duchenne muscular dystrophy typically have deletion mutations in exons [43 to 55] of the dystrophin gene, which disrupt the open-reading frame and the normal synthesis of the protein. Without dystrophin, muscle fibers become damaged during contraction resulting in inflammation and eventually replacement of muscle by fibrous and adipose tissue. Duchenne muscular dystrophy is an X-linked recessive disease that generally becomes clinically apparent by the age of 2 or 3 years, resulting in gradual loss of muscle and progressive disability often leading to loss of ambulation by age 10, ventilatory failure in early adulthood, and death in the 20s or 30s. In cell culture, antisense molecules were designed that allowed for skipping of the abnormal exon 51 found in 10% to 12% of patients with Duchenne muscular dystrophy and that replaced the defective dystrophin gene with a truncated but functional dystrophin molecule. In animal models, eteplirsen led to increases in truncated muscle dystrophin. In small clinical trials, eteplirsen was found to increase levels of dystrophin protein in muscle, on the basis of which it was approved for use in patients with Duchenne muscular dystrophy with a confirmed mutation in the dystrophin gene amenable to exon 51 skipping. Eteplirsen is available in solution in single dose vials of 100 mg or 500 mg (50 mg/mL). The recommended regimen is 30 mg per kg body weight once weekly by intravenous infusion. Side effects of eteplirsen include headache, fever, falls, abdominal pain, cough, and nausea. Injection site reactions and hypersensitivity reactions including rash, pruritus, urticaria and skin exfoliation have occurred. Because eteplirsen is infused weekly, most patients have indwelling venous access catheters placed, which may pose a risk for complications of infection and septicemia.

### Hepatotoxicity

Duchenne muscular dystrophy is a rare disease, affecting ~1:5000 newborn boys, and those with deletion mutants in exon 51 account for only 13% of patients with the disease. Because the pivotal trials of eteplirsen were conducted in small numbers of patients, the full spectrum of adverse events and hepatotoxicity may not be fully known. Nevertheless, serum aminotransferase elevations were not described in the registration trials of eteplirsen and there were reportedly no discontinuations because of adverse events. Thus, eteplirsen has not been linked to instances of acute hepatitis or jaundice, but it has had limited clinical use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

How eteplirsen might cause liver injury is not known. One possibility is that exon skipping may cause disruption of translation of other genes in hepatocytes. Eteplirsen and other antisense molecules are largely excreted unchanged in the urine and have little effect on cytochrome P450 enzyme activities or metabolism of other drugs.

### Outcome and Management

Eteplirsen therapy has not been associated with liver injury, either in the form of minor serum enzyme elevations or clinically apparent liver injury. There is no reason to suspect cross reactivity of the hepatic injury with other antisense therapies or drugs used to treat Duchenne muscular dystrophy. Regular monitoring of liver tests during therapy is not generally recommended.

Drug Class: Genetic Disorder Agents

Other Therapeutic Antisense RNA Agents for Duchenne Muscular Dystrophy: Casimersen, Golodirsen, Viltolarsen

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Eteplirsen – Exondys 51®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=33bff678-7829-479e-9110-b8e33a0bc0aa)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Eteplirsen | 1173755-55-9 | C364-H569-N177-O122-P30

## ANNOTATED BIBLIOGRAPHY

References updated: 01 December 2022

Abbreviations: siRNA, small interfering RNA.

Mendell JR, Rodino-Klapac LR, Sahenk Z, Roush K, Bird L, Lowes LP, Alfano L, et al., Eteplirsen Study Group. (2013). Eteplirsen for the treatment of Duchenne muscular dystrophy. Ann Neurol. (In a small randomized controlled trial, 12 boys with Duchenne muscular dystrophy and mutations in exon 51 of the dystrophin gene were treated with eteplirsen [30 or 50 mg/kg intravenously] or placebo once weekly for 24 weeks, after which the placebo recipients received eteplirsen; muscle biopsies taken before and at 24 and 48 weeks showed increases in dystrophin with treatment and there were no treatment related side effects and no change in liver chemistries).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to RNAi or antisense therapies or medications for muscular dystrophy).
Mendell JR, Goemans N, Lowes LP, Alfano LN, Berry K, Shao J, Kaye EM, et al., Eteplirsen Study Group and Telethon Foundation DMD Italian Network. (2016). Longitudinal effect of eteplirsen versus historical control on ambulation in Duchenne muscular dystrophy. Ann Neurol. (Follow up study of 12 patients with Duchenne muscular dystrophy treated with eteplirsen for up to 36 months [Mendell 2013] found improvements in pulmonary function tests and 6 minute walk tests in eteplirsen treated compared to historical untreated controls; therapy was well tolerated and “there was no signs of symptoms of hepatic toxicity”).
FDA. Summary Review and Evaluation. Eteplirsen. 2016. Available at: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2016/206488_summary%20review_Redacted.pdf (The FDA clinical review of eteplirsen for efficacy and safety found only marginal evidence of benefit and no major safety issues, although the number of patients treated with eteplirsen that could be evaluated were few; there were no liver related serious adverse events or discontinuations and no mention of ALT elevations during therapy).
Syed YY. (2016). Eteplirsen: first global approval. Drugs. (Review of the mechanism of action, history of development, clinical efficacy and safety of eteplirsen shortly after its approval as therapy of Duchenne muscular dystrophy in patients with confirmed mutation in exon 51 of the dystrophin gene, the approval being based upon increased dystrophin levels in muscle biopsies and not upon clinical benefit; there were no discontinuations for adverse events and “no clinically relevant effects” on liver function).
(2016). Eteplirsen (Exondys 51) for Duchenne muscular dystrophy. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of eteplirsen shortly after its approval in the US as therapy of Duchenne muscular dystrophy mentions that there was no evidence of clinical benefit of therapy and that the minimal increases in dystrophin levels in muscle were of uncertain clinical relevance; no mention of ALT elevations or hepatotoxicity).
Kesselheim AS, Avorn J. (2016). Approving a problematic muscular dystrophy drug: implications for FDA policy. JAMA. (Commentary on the approval of eteplirsen by the FDA pointing out the lack of rigor in the clinical studies on its effects and the use of a surrogate marker to assess efficacy that has never been shown to reflect or predict clinical improvement).
Chi X, Gatti P, Papoian T. (2017). Safety of antisense oligonucleotide and siRNA-based therapeutics. Drug Discov Today. (Oligonucleotide and siRNA based treatments are currently being evaluated in several diseases and have been found to have unexpected toxicities including antisense thrombocytopenia [mipomersen, drisapersen] and peripheral neuropathy [revusiran]; no discussion of hepatotoxicity).
Messina S, Vita GL. (2018). Clinical management of Duchenne muscular dystrophy: the state of the art. Neurol Sci. (Review of current optimal clinical management of Duchenne muscular dystrophy focusing upon standard respiratory, cardiovascular, orthopedic and nutritional support as well as recent innovative approaches to therapy including exon skipping and premature stop codon suppression).
Aartsma-Rus A, Arechavala-Gomeza V. (2018). Why dystrophin quantification is key in the eteplirsen saga. Nat Rev Neurol. (Editorial discussing eteplirsen which was approved based upon its effects in increasing dystrophin levels in muscle rather than a clinical effect on preventing progression of disease mentions the challenges of accurate measurement of dystrophin levels and the limited amount of uncontrolled clinical data on the effects of eteplirsen therapy on ambulation and muscle strength).
Charleston JS, Schnell FJ, Dworzak J, Donoghue C, Lewis S, Chen L, Young GD, et al. (2018). Eteplirsen treatment for Duchenne muscular dystrophy: exon skipping and dystrophin production. Neurology. (Reanalysis of the muscle biopsies from the initial trial of eteplirsen in 12 patients with Duchenne muscular dystrophy found increased levels of dystrophin after 24, 48 and 180 weeks of treatment by RT-PCR, Western blot, immunohistochemistry and immune fluorescence using untreated controls to estimate baseline levels of the protein).
Verhaart IEC, Aartsma-Rus A. (2019). Therapeutic developments for Duchenne muscular dystrophy. Nat Rev Neurol. (Review of the pathogenesis, clinical features and natural history of Duchenne muscular dystrophy and recent innovative approaches to treating the underlying genetic defect; this X-linked recessive disorder affects approximately 1 in 5000 boys and is associated with progressive loss of muscle function, presenting clinically by 2-3 years of age and leading to disability in childhood with loss of ambulation by age 12, ventilatory failure by age 20 and death during the 3rd or 4th decade of life; innovative approaches include exon skipping, genome editing, stop codon readthrough, stem cell therapy, and amelioration of secondary pathology with antiinflammatory agents and antioxidants).
Alfano LN, Charleston JS, Connolly AM, Cripe L, Donoghue C, Dracker R, Dworzak J, et al. (2019). Long-term treatment with eteplirsen in nonambulatory patients with Duchenne muscular dystrophy. Medicine (Baltimore). (Detailed description of 2 of the initial 12 patients receiving eteplirsen for Duchenne muscular dystrophy who had rapid loss of ambulation but were continued on treatment and who remained relatively stable thereafter; in long term follow up there were no serious hepatic adverse events and no mention of ALT elevations in the listing of side effects).
Khan N, Eliopoulos H, Han L, Kinane TB, Lowes LP, Mendell JR, Gordish-Dressman H, et al., Eteplirsen Investigators and the CINRG DNHS Investigators. (2019). Eteplirsen treatment attenuates respiratory decline in ambulatory and non-ambulatory patients with Duchenne muscular dystrophy. J Neuromuscul Dis. (Among 74 patients with Duchenne muscular dystrophy treated with eteplirsen and corticosteroids in 3 prospective trials, the average yearly decline in forced vital capacity was less [-2.2% to -3.8%] than in a matched, untreated control group [-6.0%]).
Levin AA. (2019). Treating disease at the RNA level with oligonucleotides. N Engl J Med. (Review of the mechanism of action, current status and future promise of RNA based therapies that use synthetic oligonucleotides to modulate RNA function and have been applied to diseases ranging from hemophilia, amyloidosis, muscular dystrophy and hyperlipidemia).
Aartsma-Rus A, Goemans N. (2019). A sequel to the eteplirsen saga: eteplirsen is approved in the United States but was not approved in Europe. Nucleic Acid Ther. (Editorial discussing eteplirsen which was approved for use in Duchenne muscular dystrophy in the US but not in Europe, controversy being about the significance of a small increase in dystrophin protein and the use of historical controls to assess efficacy in preventing progression of muscle weakness and preservation of ambulation).
Setten RL, Rossi JJ, Han SP. (2019). The current state and future directions of RNAi-based therapeutics. Nat Rev Drug Discov. (Extensive review of gene silencing using RNA interference pathways and the potential of RNAi therapeutics which has promise in many genetic and acquired diseases including transthyretin amyloidosis [transthyretin], HIV infection [CCR5], HBV [HBV mRNA], alpha-1-antitrypsin deficiency [zz A1AT], hypercholesterolemia [PCSK9]).
Verhaart IEC, Aartsma-Rus A. (2019). Therapeutic developments for Duchenne muscular dystrophy. Nat Rev Neurol. (Review of mechanisms, challenges, and clinical efficacy of new molecular approaches to therapy of muscular dystrophy including gene therapy with viral vectors, exon skipping using antisense oligonucleotides [casimersen, eteplirsen, drisapersen, golodirsen], stop coding readthrough [ataluren], gene addition, CRISPR-Cas9 genome editing, and myoblast transplantation).
Aartsma-Rus A, Corey DR. (2020). The 10th oligonucleotide therapy approved: golodirsen for Duchenne muscular dystrophy. Nucleic Acid Ther. (Review of the efficacy and safety of 10 oligonucleotide therapies approved in the US or Europe, including specific discussions of fomivirsen, mipomersen, eteplirsen, nusinersen, patisiran, givosiran and golodirsen).
Mendell JR, Khan N, Sha N, Eliopoulos H, McDonald CM, Goemans N, Mercuri E, et al., Eteplirsen Study Group. (2021). Comparison of long-term ambulatory function in patients with Duchenne muscular dystrophy treated with eteplirsen and matched natural history controls. J Neuromuscul Dis. (Among 12 ambulatory boys, aged 7 to 13, with Duchenne muscular dystrophy treated with eteplirsen for 4 years, the decline in ambulation was less than in a matched control group and loss of ambulation occurred in only 2 of 12 treated children [17%] vs 8 of 11 controls [73%]; no mention of adverse event rates).
McDonald CM, Shieh PB, Abdel-Hamid HZ, Connolly AM, Ciafaloni E, Wagner KR, Goemans N, et al., Italian DMD Telethon Registry Study Group. (2021). Leuven NMRC Registry Investigators, CINRG Duchenne Natural History Investigators, and PROMOVI Trial Clinical Investigators. Open-label evaluation of eteplirsen in patients with Duchenne muscular dystrophy amenable to exon 51 skipping: PROMOVI Trial. J Neuromuscul Dis. (Among 79 patients, ages 10 to 16 years, with Duchenne muscular dystrophy treated with eteplirsen for 96 weeks, decline in motor function was less than that in matched untreated controls, adverse events were mostly mild, there were no treatment related drug discontinuations and “eteplirsen did not appear to adversely affect clinical laboratory values”; one patient had a serious adverse event due to a venous port).
Mitelman O, Abdel-Hamid HZ, Byrne BJ, Connolly AM, Heydemann P, Proud C, Shieh PB, et al. (2022). investigators from the LNMRC Natural History study, McDonald CM; investigators from the CINRG Duchenne National History Study, Mercuri E; investigators from The DMD Italian Group, Mendell JR. A combined prospective and retrospective comparison of long-term functional outcomes suggests delayed loss of ambulation and pulmonary decline with long-term eteplirsen treatment. J Neuromuscul Dis. (In studies using multiple external historical controls, eteplirsen therapy appeared to slow disease progression in both ambulation and pulmonary status; no mention of liver related events or toxicity).
Alhamadani F, Zhang K, Parikh R, Wu H, Rasmussen TP, Bahal R, Zhong XB, Manautou JE. (2022). Adverse drug reactions and toxicity of the Food and Drug Administration-approved antisense oligonucleotide drugs. Drug Metab Dispos. (Review of the adverse side effects of oligonucleotide therapies approved in the US or Europe, including specific discussions of fomivirsen, mipomersen, nusinersen, inotersen, eteplirsen, golodirsen, viltolarsen and casimersen; hepatotoxicity has been described with use of mipomersen [now withdrawn] and inotersen, but not with the agents used for Duchenne muscular dystrophy).
Iff J, Gerrits C, Zhong Y, Tuttle E, Birk E, Zheng Y, Paul X, et al. (2022). CINRG-DNHS Investigators. Delays in pulmonary decline in eteplirsen-treated patients with Duchenne muscular dystrophy. Muscle Nerve. (In post-hoc analyses of studies of eteplirsen therapy and standard of care in 10 to 18 year old boys with Duchenne muscular dystrophy that included data on serial determinations of FVC, the estimated average rate of FVC% decline was 3.5% in children on eteplirsen vs 6.0% in controls suggesting that therapy delayed the decline in pulmonary function that leads to ventilation dependence in young adulthood in this disease; no mention of hepatic abnormalities).

## OTHER REFERENCE LINKS

1 Recent References on Eteplirsen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Eteplirsen/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900%5C%5C1%5C%5C1%22%5bEDat%5d:%222999%5C%5C12%5C%5C31%22%5bEDat%5d))
2 Trials on Eteplirsen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Eteplirsen)